# Apixaban

## OVERVIEW

### Introduction

Apixaban is an oral anticoagulant and direct inhibitor of factor Xa which is used to decrease the risk of venous thromboses, systemic embolization and stroke in patients with atrial fibrillation, and lower the risk of deep vein thrombosis and pulmonary embolus after knee or hip replacement surgery. Apixaban has been linked to a low rate of serum aminotransferase elevations during therapy and to rare instances of clinically apparent liver injury.

### Background

Apixaban (a pix' a ban) is a direct and reversible inhibitor of factor Xa (-xaban), the rate controlling last step in the generation of thrombin, the final intermediate in blood coagulation. Inhibiting thrombin prevents the conversion of fibrinogen to fibrin and subsequent cross linking of fibrin monomers, platelet activation and amplification of coagulation. Apixaban has been shown to be as effective as warfarin and more effective than aspirin in preventing stroke and systemic embolization in patients with atrial fibrillation. Clinical trials have also shown that apixaban therapy can decrease the risk of deep vein thrombosis and pulmonary embolism in patients undergoing hip or knee replacement surgery. Apixaban was approved for use in the United States in 2012, the second oral factor Xa to be approved. Current indications are for prevention of stoke and systemic embolism in patients with nonvalvular atrial fibrillation, prevention of deep vein thrombosis after hip or knee replacement surgery, treatment of deep vein thrombosis and pulmonary embolism, and reduction in risk of recurrence of deep vein thrombosis or pulmonary embolism. Apixaban is available in 2.5 and 5 mg tablets generically and under the commercial name Eliquis. The usual dose is 2.5 or 5 mg twice daily and varies somewhat by indication. Unlike warfarin, apixaban and the other oral direct thrombin and factor Xa inhibitors do not require monitoring of bleeding time or INR. Side effects are not common, but can include bleeding, headache, dizziness, fatigue, gastrointestinal upset, nausea, arthralgias and rash. Uncommon, but potentially severe adverse events include severe bleeding episodes and hypersensitivity reactions. Severe adverse events include major bleeding episodes, epidural or spinal hematoma, and increase in risk of thrombotic events with premature discontinuation.

### Hepatotoxicity

Apixaban is associated with serum aminotransferase elevations greater than 3 times the upper limit of normal in 1% to 2% of treated patients. This rate is similar or lower than rates with warfarin or comparator arms. In premarketing studies, no instances of clinically apparent liver injury were reported, but subsequent to its approval and more wide scale use, several reports of mild but clinically apparent liver injury have been published. The liver injury arose within days of starting apixaban and the pattern of liver enzyme elevations was hepatocellular. Immunoallergic and autoimmune features were not present. In most cases, recovery was rapid once apixaban was stopped. In one analysis of a national health care database, the incidence of hospitalization for acute liver injury after initiation of apixaban therapy was 1 per 2,200 patients treated, a rate similar to that of rivaroxaban.

Likelihood score: B (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Apixaban is metabolized in the liver predominantly via the cytochrome P450 system, CYP 3A4, and P-glycoprotein, and potent inhibitors of CYP 3A4 (such as itraconazole, ritonavir and clarithromycin) can cause elevated levels of apixaban, while inducers of CYP 3A4 (such as rifampin or phenytoin) can lead to reduced and ineffective levels of the anticoagulant. Liver injury from apixaban may be due to production of a toxic or immunogenic intermediate.

### Outcome and Management

The severity of liver injury associated with apixaban has ranged from mild, asymptomatic and self-limited elevations in serum aminotransferases to hepatitis with mild jaundice. Recovery is usually rapid once apixaban is stopped, but at least one case of fulminant hepatitis and death has been reported. There have been no reports of chronic hepatitis or vanishing bile duct syndrome attributed to apixaban use. In some instances, patients with acute liver injury due to one direct factor Xa inhibitor (rivaroxaban) have tolerated another (apixaban) without recurrence of liver abnormalities.

Drug Class: Antithrombotic Agents, Anticoagulants

Other Drugs in the Subclass, Anticoagulants, Factor Xa Antagonists: Betrixaban, Edoxaban, Fondaparinux, Rivaroxaban

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Apixaban – Generic, Eliquis®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Apixaban)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Apixaban | 503612-47-3 | C25-H25-N5-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 16 February 2023

Zimmerman HJ. Platelet aggregation inhibitors. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-412. (Textbook of hepatotoxicity published in 1999 well before the availability of apixaban and the direct Factor Xa inhibitors).
De Marzio DH, Navarro VJ. Antiplatelet agents. Hepatotoxicity of cardiovascular and antidiabetic drugs: antihypertensives. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 527-8. (Review of hepatotoxicity of cardiovascular drugs does not discuss the anticoagulants).
Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 849-76. (Textbook of pharmacology and therapeutics).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were due to anticoagulants).
Huang J, Cao Y, Liao C, Wu L, Gao F. (2011). Apixaban versus enoxaparin in patients with total knee arthroplasty. A meta-analysis of randomised trials. Thromb Haemost. (Systematic review of 3 trials of apixaban versus enoxaparin in 3773 patients undergoing knee replacement surgery found lower rates of deep vein thrombosis and pulmonary embolism with apixaban than enoxaparin, and little or no difference in rates of bleeding [2.6% vs 3.4%] or rates of ALT and AST elevations above 3 times ULN [1.3% vs 1.4%]).
Granger CB, Alexander JH, McMurray JJ, Lopes RD, Hylek EM, Hanna M, Al-Khalidi HR, et al., ARISTOTLE Committees and Investigators. (2011). Apixaban versus warfarin in patients with atrial fibrillation. N Engl J Med. (Among 18,201 patients with atrial fibrillation enrolled in a prospective controlled trial, stroke or systemic embolization occurred in 1.3% of apixaban- vs 1.6% of the warfarin-treated patients and rates of both total and serious adverse events were similar in the two groups, ALT elevations above 3 times ULN occurring in 1.1% vs 1.0% and the combination of ALT or AST and bilirubin elevation in 0.3% vs 0.4%).
Connolly SJ, Eikelboom J, Joyner C, Diener HC, Hart R, Golitsyn S, Flaker G, et al., AVERROES Steering Committee and Investigators. (2011). Apixaban in patients with atrial fibrillation. N Engl J Med. (Among 5599 patients with atrial fibrillation treated with apixaban or aspirin, stroke or systemic embolism occurred in 1.5% of patients per year on apixaban compared to 3.7% per year on aspirin; bleeding rates were similar and rates of ALT elevations were not reported).
(2013). Apixaban (Eliquis)--a new oral anticoagulant for atrial fibrillation. Med Lett Drugs Ther. (Concise review of efficacy and safety of apixaban for prevention of stroke or systemic embolization in patients with nonvalvular atrial fibrillation which is equivalent or better in efficacy than warfarin with a lower rate of bleeding; no mention of hepatotoxicity or ALT elevations).
Caldeira D, Barra M, Santos AT, de Abreu D, Pinto FJ, Ferreira JJ, Costa J. (2014). Risk of drug-induced liver injury with the new oral anticoagulants: systematic review and meta-analysis. Heart. (Systematic review of 29 controlled trials of oral anticoagulants in 152,116 patients focusing on risk of drug induced liver injury [including 7 trials with 22,992 patients on apixaban] found no increase in rate of serum ALT or AST elevations above 3 times ULN [1.0% vs 1.2%], or combined enzyme and bilirubin elevations above 2 times ULN [both 0.2%] with apixaban therapy compared to control patients on standard therapy).
(2014). New oral anticoagulants for acute venous thromboembolism. Med Lett Drugs Ther. (Brief comparison of warfarin, rivaroxaban, apixaban and dabigatran as anticoagulants to treatment of venous thromboembolism all of which have similar efficacy, warfarin requiring regular monitoring of INR whereas the others do not).
Liakoni E, Rätz Bravo AE, Krähenbühl S. (2015). Hepatotoxicity of new oral anticoagulants (NOACs). Drug Saf. (Systematic review of evidence of hepatotoxicity of new oral anticoagulants including rivaroxaban, apixaban, edoxaban and dabigatran found 22 cases of liver injury due to rivaroxaban, 2 dabigatran, 2 apixaban, but none to edoxaban).
Anastasia EJ, Rosenstein RS, Bergsman JA, Parra D. (2015). Use of apixaban after development of suspected rivaroxaban-induced hepatic steatosis; a case report. Blood Coagul Fibrinolysis. (67 year old man developed ALT elevations 6 months after starting rivaroxaban [peak ALT 391 U/L, Alk P 120 U/L, bilirubin 1.3 mg/dL], which fell into the normal range within 2 months of switching to apixaban; ultrasound suggested fatty liver which also resolved with stopping).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, two cases were attributed to anticoagulants (prasugrel and dalteparin), but none to apixaban or other direct factor Xa antagonists).
Cordeanu M, Lambert A, Gaertner S, Nouri S, Mirea C, Alt-Tebacher M, Stephan D. (2016). Apixaban-induced hepatotoxicity. Int J Cardiol. (72 year old woman developed asymptomatic elevations in serum enzymes 4 days after restarting apixaban and 7 days after pacemaker implantation [bilirubin normal, ALT ~185 U/L, Alk P ~120 U/L], values returning to normal within 16 days of stopping).
Clarke SA, Alsaad AA, Mack A, Phillips MB. (2016). Apixaban-induced liver injury. BMJ Case Rep. (81 year old woman with atrial fibrillation developed weakness and abdominal pain 3 days after starting apixaban [bilirubin 2.5 mg/dL, ALT 199 U/L, Alk P 72 U/L], abnormal values falling into the normal range within 7 days of stopping).
Alonso A, MacLehose RF, Chen LY, Bengtson LG, Chamberlain AM, Norby FL, Lutsey PL. (2017). Prospective study of oral anticoagulants and risk of liver injury in patients with atrial fibrillation. Heart. (Analysis of a database on more than 1 million patients with nonvalvular atrial fibrillation on oral anticoagulants identified 960 hospitalizations with liver injury, rates being highest for warfarin, intermediate for rivaroxaban, and lowest for apixaban and dabigatran).
Pasin F, Esteban MDP, Testa S. (2019). Apixaban-induced fatal liver injury with a cholestatic pattern: A case report and brief review of the literature. Eur J Intern Med. (87 year old woman with atrial fibrillation developed jaundice 5 weeks after starting apixaban [bilirubin 36 mg/dL, ALT 36 times ULN, Alk P 2 times ULN, INR not given], with progressive hepatic failure despite stopping therapy leading to death 21 days after admission).
Machlab S, Miquel M, Vergara M, Escoda MR, Casas M. (2019). Apixaban-induced liver injury. Rev Esp Enferm Dig. (85 year old woman with atrial fibrillation was found to have abnormal liver tests 3 months after starting apixaban [bilirubin 0.6 mg/dL, ALT 327 U/L, Alk P 343 U/L, GGT 2378 U/L], with rapid improvement upon switching to tinzaparin).
Björnsson HK, Gudmundsson DO, Björnsson ES. (2020). Liver injury caused by oral anticoagulants: A population-based retrospective cohort study. Liver Int. (Search of Icelandic National Prescription Databases and Health Records identified 3 cases of clinically apparent, acute liver injury in 3 of 3446 [0.1%] patients taking rivaroxaban, but in none of 9101 taking warfarin, 1903 apixaban, 1335 dabigatran or 34 taking edoxaban).
Zhao J, Blais JE, Chui CSL, Suh IH, Chen EYH, Seto WK, Mok MT, et al. (2020). Association between nonvitamin K antagonist oral anticoagulants or warfarin and liver injury: a cohort study. Am J Gastroenterol. (Among 13,698 patients with atrial fibrillation started on anticoagulant therapy and followed in the Hong Kong Clinical Database and Reporting system between 2010 and 2016, 513 [2.8%] developed evidence of liver injury and propensity matching indicated that liver injury was less frequent [2.1% vs 3.4%], although more severe with oral anticoagulants than with warfarin).
Maura G, Bardou M, Billionnet C, Weill A, Drouin J, Neumann A. (2020). Oral anticoagulants and risk of acute liver injury in patients with nonvalvular atrial fibrillation: a propensity-weighted nationwide cohort study. Sci Rep. (Among 434,015 patients with atrial fibrillation started on anticoagulant therapy and followed in the French National Healthcare Database, 218 [0.6%] were subsequently hospitalized for acute liver injury, the rates being similar for those on dabigatran [26 of 51,737 patients], apixaban [29 of 62,503 patients] and rivaroxaban [46 of 99,408 patients]).
Zhou J, Leung KSK, Kong D, Lee S, Liu T, Wai AKC, Chang C, et al. (2021). Low rates of liver injury in edoxaban users: Evidence from a territory-wide observational cohort study. Clin Cardiol. (Among 1213 patients with atrial fibrillation started on edoxaban between 2016 and 2020 and followed in the Hong Kong Clinical Database and Reporting System, 19 [1.5%] developed evidence of liver injury, a rate below that previously reported for warfarin [3.7%], apixaban [2.5%], and rivaroxaban [2.1%]).
Rao V, Munasinghe A. (2021). Acute liver failure after changing oral anticoagulant from apixaban to rivaroxaban. BMJ Case Rep. (88 year old man with atrial fibrillation was switched from apixaban to rivaroxaban [15 mg daily] after experiencing a transient ischemic attack and developed jaundice 2 weeks later [bilirubin 11.2 mg/dL, ALT 1940 U/L, Alk P 360 U/L] but no hepatic encephalopathy, recovering rapidly upon switching to warfarin).
Ma J, Chalasani NP, Schwantes-An L, Björnsson ES. (2023). Review article: the safety of anticoagulants and antiplatelet agents in patients with cirrhosis. Aliment Pharmacol Ther. (Review of the safety of anticoagulant use in patients with cirrhosis mentions that drug induced liver injury is uncommon in patients with preexisting cirrhosis, at least in those with compensated [Child’s Class A] or mildly compensated [Child’s Class B] cirrhosis).

## OTHER REFERENCE LINKS

1 Recent References on Apixaban: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Apixaban/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Apixaban: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Apixaban)